# Eculizumab

## OVERVIEW

### Introduction

Eculizumab is a humanized monoclonal antibody to complement factor 5 which acts to block complement activation and is used to treat paroxysmal nocturnal hemoglobinuria and hemolytic uremic syndrome. Eculizumab has been linked to several instances of serum enzyme elevations after repeated infusions and to rare instances of clinically apparent acute liver injury.

### Background

Eculizumab (e" kue liz' ue mab) is a recombinant, humanized IgG monoclonal antibody to complement factor 5, which inhibits its enzymatic cleavage and activation. Activated complement is an important mediator of immune damage including hemolysis of red blood cells and plays an essential role in the hemolysis and tissue damage that accompanies paroxysmal nocturnal hemoglobinuria (PNH) and hemolytic uremic syndrome (HUS). In clinical trials in PNH, eculizumab was found to reduce hemolysis and the need for blood transfusions with subsequent improvement in symptoms and quality of life. Eculizumab was approved for use in PNH in the United States in 2007. The indications were later broadened to include atypical hemolytic uremic syndrome with complement-mediated thrombotic events in 2011. Eculizumab is available as a solution in single dose vials of 300 mg in 30 mL (10 mg/mL) under the commercial name Soliris. The recommended dose varies by body weight and indication, but it is typically given by intravenous infusion (over 35 minutes) weekly for 5 weeks and every two weeks thereafter. Side effects are not common, but can include headache, diarrhea, nausea, fatigue and upper respiratory tract infections. Rare, but potentially severe adverse reactions include serious infections, including meningococcal infections, for which reason eculizumab is available only as a part of a risk evaluation and mitigation strategy (REMS) that requires physician training in its use and enrollment of the patient in a surveillance program.

### Hepatotoxicity

In clinical trials of eculizumab in patients with PNH and atypical HUS, serum enzyme levels were rarely mentioned and laboratory test results were described as being stable or unremarkable. In preregistration studies of eculizumab there were no reports of clinically apparent liver injury with jaundice. Indeed, in many studies, a steady improvement in ALT and AST values during treatment was described, perhaps reflecting the decrease in intravascular hemolysis that occurred. After approval and more widespread use of eculizumab, however, a case series of eculizumab therapy in 11 children with atypical HUS, reported that 5 children developed marked serum enzyme elevations during therapy that was accompanied by jaundice in three cases and led to discontinuation of treatment in one patient after development of symptoms and jaundice (Case 1). The onset of injury was within the first 4 doses of eculizumab and tended to recur with subsequent doses, but to a lesser extent. Indeed, 4 children were able to continue eculizumab therapy without recurrence. The pattern of serum enzyme elevations was mixed. There was no mention of immunoallergic symptoms or autoantibody formation. Similar cases have not been reported in other case series or clinical trials. Thus, liver injury may occur with eculizumab therapy but it is typically mild, asymptomatic and self-limited in course, not requiring dose modification or discontinuation. There have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome associated with eculizumab therapy.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which eculizumab might cause liver injury is unknown. Eculizumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity. Because it blocks the activation of complement, it might predispose to conditions that depend on complement activation for resolution (such as meningococcemia), but it is not clear whether this applies to any liver diseases.

### Outcome and Management

Eculizumab therapy has been linked to rare instances of mild, transient serum enzyme elevations during therapy, typically arising 1 to 3 weeks after an initial or early infusion of the monoclonal antibody. Instances of jaundice and symptoms from liver injury with eculizumab therapy are rare and not well described, but there have been no reports of acute liver failure, chronic hepatitis, cirrhosis or vanishing bile duct syndrome associated with it use. In patients who develop persistent elevations of serum ALT or alkaline phosphatase or who develop jaundice and symptoms, therapy should be interrupted.

Drug Class: Hematologic Agents, Monoclonal Antibodies

## CASE REPORT

### Case 1. Mixed hepatocellular-cholestatic liver injury during eculizumab therapy.

[Modified from Case 1 in: Hayes W, Tschumi S, Ling SC, Feber J, Kirschfink M, Licht C. Eculizumab hepatotoxicity in pediatric aHUS. Pediatr Nephrol 2015; 30: 775-81. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/25416628)]

A 9 year old boy with atypical hemolytic uremic syndrome was found to have marked elevations in serum aminotransferase and alkaline phosphatase levels 3 days after a second dose of eculizumab. All liver tests had been normal before treatment, and ALT values were normal on several occasions in the week after the initial dose and at the time of the second. The values fluctuated widely rising to a peak ALT of 908 U/L, AST 1107 U/L and alkaline phosphatase 1023 U/L. He had mild symptoms of right upper quadrant pain and liver tenderness, but serum albumin and INR remained normal (bilirubin not mentioned). Tests for viral hepatitis and autoimmune markers were negative and liver ultrasound showed hepatomegaly and an heterogenous liver texture, but no evidence of biliary obstruction. A liver biopsy showed minimal changes with mild hepatocellular cytoplasmic swelling and clearing, mild Kupffer cell hemosiderosis, mild pericentral sinusoidal dilation and fibrosis. Serum enzyme elevations soon fell into the normal range and he received a third infusion 3 weeks after the second. Three days later, his serum enzymes were again elevated and he was jaundiced with a direct bilirubin of 9.9 mg/dL (previously 0.0). Therapy was suspended and liver tests began to improve and were reportedly normal 4 weeks later.

#### Key Points

Medication: | Eculizumab (900 mg infusions)
Pattern: | Mixed (R=2.6 from peak values)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 11 days
Recovery: | 4 weeks
Other medications: | None mentioned

#### Comment

In a small case series, 5 of 11 children with atypical HUS treated with eculizumab developed evidence of liver injury after 1 to 4 doses of the monoclonal antibody. All five were known to have had normal serum enzymes before starting treatment and in several instances the elevations recurred with a subsequent infusion. Nevertheless, all except the case described here recovered and were able to tolerate further doses of eculizumab without recurrence of liver injury. This article is the only description of liver injury from this monoclonal antibody and came as a surprise, because of the lack of hepatotoxicity noted in previous publications despite careful descriptions of several hundred patients with either HUS or PND who received eculizumab. The pattern of injury was "mixed" with marked elevations in aminotransferase as well as alkaline phosphatase and GGT levels. Also striking was the rapidity of onset and rapidity of resolution suggesting a direct effect on hepatic function rather than hepatocellular damage. A liver biopsy was performed, but at a time when the abnormalities had almost resolved. The biopsy showed hepatocellular swelling rather than necrosis and cell loss. Thus, the liver injury attributed to eculizumab is unusual and suggestive of a direct effect of the monoclonal antibody on hepatocyte pathways rather than direct cell damage.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eculizumab – Soliris®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eculizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Eculizumab | 219685-50-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 March 2017

Abbreviations used: HUS, hemolytic uremic syndrome; LDH, lactic dehydrogenase; PNH, paroxysmal nocturnal hemoglobinuria.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; eculizumab is not specifically mentioned).
Krensky AM, Vincenti F, Bennett WM. Immunomodulators. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1405-88. (Textbook of pharmacology and therapeutics).
Hillmen P, Lewis SM, Bessler M, Luzzatto L, Dacie JV. Natural history of paroxysmal nocturnal hemoglobinuria. N Engl J Med 1995; 333: 1253-8. (Among 80 patients with PNH seen at a single London referral center between 1940 and 1970, ages 16 to 73 at diagnosis, the median survival was 10 years and causes of death were often hemorrhage or serious thrombotic events). 7566002
Hillmen P, Hall C, Marsh JC, Elebute M, Bombara MP, Petro BE, Cullen MJ, et al. Effect of eculizumab on hemolysis and transfusion requirements in patients with paroxysmal nocturnal hemoglobinuria. N Engl J Med 2004; 350: 552-9. (Among 11 patients with transfusion dependent PNH treated with eculizumab, transfusion requirements, episodes of hemolysis and LDH levels decreased and quality of life improved; no adverse events were attributed to therapy except for rare infusion reactions). 14762182
Hillmen P, Young NS, Schubert J, Brodsky RA, Socié G, Muus P, Röth A, et al. The complement inhibitor eculizumab in paroxysmal nocturnal hemoglobinuria. N Engl J Med 2006; 355: 1233-43. (Among 87 patients with PNH treated with eculizumab or placebo by iv infusion every 1-2 weeks for 26 weeks, median transfusion numbers were less with eculizumab compared to placebo [0 to 10], LDH levels decreased [86%] and quality of life improved significantly, while adverse events were more common including headache, body pain, and fatigue while serious adverse events were less common with eculizumab vs placebo, and none were liver related or considered related to therapy). 16990386
Noris M, Remuzzi G. Atypical hemolytic-uremic syndrome. N Engl J Med 2009; 361: 1676-87. (HUS occurs most commonly in children after E. coli 0157:H7 infection and is marked by bloody diarrhea followed by hemolysis, thrombocytopenia and renal dysfunction; about 10% of cases of HUS are considered "atypical", occurring without known bacterial infection and having a poor prognosis, some being genetic and some sporadic, marked by abnormalities in complement activation and its regulation). 19846853
Röth A, Hock C, Konik A, Christoph S, Dührsen U. Chronic treatment of paroxysmal nocturnal hemoglobinuria patients with eculizumab: safety, efficacy, and unexpected laboratory phenomena. Int J Hematol 2011; 93: 704-14. (Among 19 patients with PNH treated with eculizumab for 6-46 months, LDH levels decreased by 85% and transfusion requirements by 86%, but other indices of hemolysis changed little [haptoglobin and bilirubin levels, reticulocytes] while ferritin levels rose [mean levels from 104 to 528 µg/L]; no discussion of adverse events). 21611719
Legendre CM, Licht C, Muus P, Greenbaum LA, Babu S, Bedrosian C, Bingham C, et al. Terminal complement inhibitor eculizumab in atypical hemolytic-uremic syndrome. N Engl J Med 2013; 368: 2169-81. (Among 37 children with atypical HUS treated with eculizumab, symptoms and signs of disease improved in most children and no serious infection related events occurred; no mention of ALT elevations or hepatotoxicity). 23738544
Kanakura Y, Ohyashiki K, Shichishima T, Okamoto S, Ando K, Ninomiya H, Kawaguchi T, et al. Long-term efficacy and safety of eculizumab in Japanese patients with PNH: AEGIS trial. Int J Hematol 2013; 98: 406-16. (Among 27 Japanese patients with PNH treated with eculizumab for up to 2 years, intravascular hemolysis and transfusion requirements decreased and adverse events were uncommon, but included headache and diarrhea, usually early in treatment; no mention of ALT elevations or hepatotoxicity). 23934275
Hillmen P, Muus P, Röth A, Elebute MO, Risitano AM, Schrezenmeier H, Szer J, et al. Long-term safety and efficacy of sustained eculizumab treatment in patients with paroxysmal nocturnal haemoglobinuria. Br J Haematol 2013; 162: 62-73. (Among 195 patients with PNH treated with eculizumab long term, there were 4 deaths, but none considered related to therapy; there were no liver related serious adverse events and no mention of ALT elevations or hepatotoxicity). 23617322
Reiss UM, Schwartz J, Sakamoto KM, Puthenveetil G, Ogawa M, Bedrosian CL, Ware RE. Efficacy and safety of eculizumab in children and adolescents with paroxysmal nocturnal hemoglobinuria. Pediatr Blood Cancer 2014; 61: 1544-50. (Among 7 children or adolescents with PNH treated with eculizumab for 12 weeks, there were no hepatic serious adverse events and no mention of ALT elevations). 24777716
Brodsky RA. Paroxysmal nocturnal hemoglobinuria. Blood 2014; 124: 2804-11. (Review of the pathophysiology, genetic causes, diagnosis, classification, clinical features and treatment of PNH; no mention of adverse effects of eculizumab). 25237200
Licht C, Greenbaum LA, Muus P, Babu S, Bedrosian CL, Cohen DJ, Delmas Y, et al. Efficacy and safety of eculizumab in atypical hemolytic uremic syndrome from 2-year extensions of phase 2 studies. Kidney Int 2015; 87: 1061-73. (Among 37 patients with atypical HUS enrolled in two open label studies of eculizumab, clinical improvements in hematologic features and renal function occurred in both studies and there were "no new safety concerns or meningococcal infections"; no mention of ALT elevations or hepatotoxicity). 25651368
Hayes W, Tschumi S, Ling SC, Feber J, Kirschfink M, Licht C. Eculizumab hepatotoxicity in pediatric aHUS. Pediatr Nephrol 2015; 30: 775-81. (Among 11 children with atypical HUS treated with eculizumab, liver test abnormalities above 3 times ULN arose in 5 after 1 to 4 doses [peak direct bilirubin 0.5-9.9 mg/dL, ALT 129-908 U/L, AST 244-1039 U/L, Alk P 173-1023, all values having been normal before treatment], which resolved despite continuing therapy in 4 who were asymptomatic, but required discontinuation in one who became jaundiced and acutely symptomatic but recovered upon stopping after a third dose). 25416628
Mallett A, Hughes P, Szer J, Tuckfield A, Van Eps C, Cambell SB, Hawley C, et al. Atypical haemolytic uraemic syndrome treated with the complement inhibitor eculizumab: the experience of the Australian compassionate access cohort. Intern Med J 2015; 45: 1054-65. (Among 10 patients with atypical HUS treated with eculizumab for an average of 3 years, all had a beneficial clinical response; no mention of ALT elevations or liver related adverse events). 26247170
Greenbaum LA, Fila M, Ardissino G, Al-Akash SI, Evans J, Henning P, Lieberman KV, et al. Eculizumab is a safe and effective treatment in pediatric patients with atypical hemolytic uremic syndrome. Kidney Int 2016; 89: 701-11. (Among 22 children with atypical HUS treated with eculizumab for 26 weeks, 14 had a complete resolution of thrombotic microangiopathy and several more had a hematologic response; most adverse events were considered unrelated to treatment and “elevated levels of ALT and AST were noted in some patients before and after receiving eculizumab”, but these normalized by week 26). 26880462
Ninomiya H, Obara N, Chiba S, Usuki K, Nishiwaki K, Matsumura I, Shichishima T, et al. Interim analysis of post-marketing surveillance of eculizumab for paroxysmal nocturnal hemoglobinuria in Japan. Int J Hematol 2016; 104: 548-558. (Among 319 Japanese patients with PNH treated with eculizumab and enrolled in postmarketing surveillance, the most common adverse events reported were headache [22%] and there were 20 deaths, none of liver failure, but one attributed to liver cancer). 27464489
Fakhouri F, Hourmant M, Campistol JM, Cataland SR, Espinosa M, Gaber AO, Menne J, et al. Terminal complement inhibitor eculizumab in adult patients with atypical hemolytic uremic syndrome: a single-arm, open-label trial. Am J Kidney Dis 2016; 68: 84-93. (Among 41 adults with atypical hemolytic uremic syndrome treated with eculizumab in two prospective, open label studies, there were significant improvements in hematologic, renal and quality of life features; two patients developed meningococcal infections and ALT levels were elevated in 34% of patients before and "transient liver enzyme level elevations were observed during the study", but most values were abnormal in only 8% of patients by the end of treatment). 27012908

## OTHER REFERENCE LINKS

1. Recent References on Eculizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Eculizumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Eculizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eculizumab)